# Berberine

## OVERVIEW

### Introduction

Berberine is a quaternary ammonia compound found in many botanical products, including goldenseal, barberry and Oregon grape, which is used for its purported antioxidant and antimicrobial properties for a host of conditions, including obesity, diabetes, hyperlipidemia, heart failure, H. pylori infection and colonic adenoma prevention. Berberine has not been linked to serum aminotransferase elevations during therapy nor to instances of clinically apparent liver injury.

### Background

Berberine is an isoquinoline alkaloid that is found in many plants and is purported to have antioxidant, antimicrobial, antiinflammatory and antineoplastic activities. It has been used in Ayurvedic as well as traditional Chinese medicine for a wide variety of conditions, including infections, diarrhea, bronchitis and digestive complaints. Berberine is found in many plants and in particularly high concentrations in Hydrastis canadensis (goldenseal), Coptis chinensis (coptis or goldenthread), Berberis aquifolium (Oregon grape), Berberis vulgaris (barberry) and Berberis aristata (tree turmeric). Berberine has been extensively evaluated in vitro and in vivo and demonstrates antioxidant, antiproliferative, and antimicrobial activities. It has been reported to be beneficial in alleviating symptoms of arthritis, in improving glucose control and insulin resistance, in improving hyperlipidemia and lowering blood pressure. Nevertheless, berberine has not been approved for any of these uses in the United States. Berberine is widely available over-the-counter in varying concentrations alone and combined with other herbs and nutritional substances in many multiingredient dietary supplements. The usual recommended dose of the herbal product is 250 to 500 mg two or three times daily. Side effects are few and largely mild and transient gastrointestinal symptoms of nausea, abdominal bloating, diarrhea or constipation. In most controlled studies, adverse events were no more frequent with berberine than with placebo and serious adverse events have been rare.

### Hepatotoxicity

Berberine has not been linked to serum enzyme elevations during therapy, although there have been few prospective studies in humans that have reported on its effects on laboratory test results in any detail. In published trials, berberine has appeared to be well tolerated with only minor and few adverse effects which have been similar in frequency among persons receiving placebo. Despite wide scale use as an herbal supplement, berberine has not been linked to published instances of clinically apparent liver injury. The frequency of hypersensitivity reactions to berberine is also not known.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Goldenseal, Oregon grape, Tree turmeric.

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Berberine – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/1126.html)

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/Goldenseal) [Goldenseal]

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Berberine | 2086-83-1 | C20-H18-N-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 06 October 2020

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications linked to liver injury are discussed, but berberine is not mentioned).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbals does not mention berberine or goldenseal).
PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007. (Compilation of short monographs on herbal medications and dietary supplements includes section on goldseal largely focused upon berberine).
Zeng XH, Zeng XJ, Li YY. (2003). Efficacy and safety of berberine for congestive heart failure secondary to ischemic or idiopathic dilated cardiomyopathy. Am J Cardiol. (Among 159 Chinese adults with congestive heart failure treated with conventional therapy with or without berberine [1.2 to 2 g/day] for a mean of 24 months, berberine therapy resulted in improvements in cardiac function and reduced mortality [9% vs 16%] with a “nonsignificant trend towards” an increase in side effects; no mention of ALT elevations or hepatotoxicity).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none were specifically attributed to a product containing berberine or goldenseal).
Yin J, Xing H, Ye J. (2008). Efficacy of berberine in patients with type 2 diabetes mellitus. Metabolism. (In 2 placebo controlled trials of berberine for 3 months in 36 and 48 patients with type 2 diabetes, therapy led to improvements in HbA1c and fasting blood glucose levels compared to placebo, and there were no “significant changes” in ALT levels or doubling of baseline ALT values in any patient).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none were attributed to berberine).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling, and the frequent underreporting of herbal use by patients. Regulation of HDS is under DSHEA, which requires manufacturers to determine safety and prohibits claims of efficacy in treating specific diseases. The US Pharmacopeia sets standards for food and drugs and includes HDS; HDS induced liver injury is a growing problem and currently accounts for at least 10% of cases of acute liver injury due to medications).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; no mention of berberine or goldenseal).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to berberine).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but berberine was not listed or mentioned).
Dong H, Zhao Y, Zhao L, Lu F. (2013). The effects of berberine on blood lipids: a systemic review and meta-analysis of randomized controlled trials. Planta Med. (Systematic review of the literature identified 11 randomized controlled trials of berberine [all from China] in 874 patients with hyperlipidemia that overall found significant declines in total and LDL cholesterol and triglycerides and a “remarkable” increase in HDL cholesterol compared to placebo, and “no serious adverse effects”, minor adverse events being largely gastrointestinal; no mention of ALT elevations or hepatotoxicity).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a product containing berberine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea; no case was attributed to berberine [Navarro et al Hepatology 2014]).
Lan J, Zhao Y, Dong F, Yan Z, Zheng W, Fan J, Sun G. (2015). Meta-analysis of the effect and safety of berberine in the treatment of type 2 diabetes mellitus, hyperlipemia and hypertension. J Ethnopharmacol. (Metaanalysis of 27 randomized controlled trials of berberine for type 2 diabetes and hypertension in 2569 patients found that its effects were similar to those of oral hypoglycemic agents and superior to placebo and that there were no serious adverse events, minor side effects being nausea, diarrhea, constipation, abdominal bloating and pain that were usually transient and did not require dose adjustment or discontinuation; no mention of hepatotoxicity).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products, but does not mention or list berberine).
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not mention or list berberine).
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. (2017). Liver injury from herbal and dietary supplements. Hepatology. (Review of the problems of liver injury and HDS products, mentions that multiingredient dietary supplements account for the major of cases, but does not mention a product with berberine as a component).
Guarino G, Strollo F, Carbone L, Della Corte T, Letizia M, Marino G, Gentile S. (2017). Bioimpedance analysis, metabolic effects and safety of the association Berberis aristata/Bilybum marianum: a 52-week double-blind, placebo-controlled study in obese patients with type 2 diabetes. J Biol Regul Homeost Agents. (Among 136 obese subjects with type 2 diabetes and metabolic syndrome who were placed on a regimen of diet and exercise and treated with berberine [500 mg] combined with silymarin [105 mg] versus placebo twice daily for 6 months, improvements in HbA1c, LDL, HDL, total cholesterol, and triglyceride levels were greater with berberine therapy, and side effects were similar in both groups as well as laboratory values that included ALT levels that “changed similarly in both groups”).
Zhang D, Ke L, Ni Z, Chen Y, Zhang LH, Zhu SH, Li CJ, Shang L, Liang J, Shi YQ. (2017). Berberine containing quadruple therapy for initial Helicobacter pylori eradication: An open-label randomized phase IV trial. Medicine (Baltimore). (Among 612 adult with H. pylori infection treated with clarithromycin, amoxicillin, and omeprazole with either berberine or bismuth for 14 days, eradication rates were similar [90% vs 86%] while adverse events were slightly higher with berberine [36% vs 29%], including nausea [12% vs 4%]; no mention of ALT elevations or hepatotoxicity).
Chen YX, Gao QY, Zou TH, Wang BM, Liu SD, Sheng JQ, Ren JL, et al. (2020). Berberine versus placebo for the prevention of recurrence of colorectal adenoma: a multicentre, double-blinded, randomized controlled study. Lancet Gastroenterol Hepatol. (Among 891 Chinese patients with adenomatous polyps on colonoscopy treated with either berberine or placebo for 2 years, recurrence of adenoma was less frequent with berberine [36% vs 47%] while there were no serious adverse events; no mention of ALT elevations or hepatotoxicity).
Mandal SK, Maji AK, Mishra SK, Ishfaq PM, Devkota HP, Silva AS, Das N. (2020). Goldenseal (Hydrastis canadensis L.) and its active constituents: A critical review of their efficacy and toxicological issues. Pharmacol Res. (Review of the chemical ingredients, pharmacologic activities, clinical efficacy and safety of goldenseal extracts in the treatment of many conditions, including obesity, hyperlipidemia, diabetes, hypertension, bacterial, fungal and viral infections, cancer, arthritis, Alzheimer disease, renal and liver disease with short discussions of toxicity, which were largely limited to in vitro and in vivo studies; no mention of ALT elevations or hepatotoxicity in humans).

## OTHER REFERENCE LINKS

1 Recent References on Berberine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Berberine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Berberine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Berberine)